# Fosinopril

## OVERVIEW

### Introduction

Fosinopril is an angiotensin-converting enzyme (ACE) inhibitor used in the therapy of hypertension and heart failure. Fosinopril is associated with a low rate of transient serum aminotransferase elevations during therapy and has been linked to rare instances of acute liver injury.

### Background

Fosinopril (fos sin' oh pril) is an ACE inhibitor approved for use alone or in combination with other agents as therapy of hypertension and heart failure. Like other ACE inhibitors, fosinopril inhibits the conversion of angiotensin I, a relatively inactive molecule, to angiotensin II which is the major mediator of vasoconstriction and volume expansion induced by the renin-angiotensin system. Other enzymes besides that which converts angiotensin I to II may also be inhibited, which may account for some of the dose related side effects of the ACE inhibitors. Fosinopril was approved for use in the United States in 1991 and is available in 10, 20 and 40 mg tablets in generic forms and under the trade name Monopril. The typical dose in adults is 10 mg once daily initially, with gradual adjustment based upon blood pressure response and tolerance. The usual maintenance dosage is 20 to 40 mg daily and the maximum 80 mg in one or two divided doses administered long term. Fosinopril is also available in fixed combinations with hydrochlorothiazide (Monopril HCT). Common side effects include dizziness, fatigue, headache, cough, gastrointestinal upset and skin rash.

### Hepatotoxicity

Fosinopril, like other ACE inhibitors, has been associated with a low rate of serum aminotransferase elevations (<2%) that, in controlled trials, was no higher than with placebo therapy. These elevations were transient and rarely required dose modification. Rare instances of clinically apparent acute liver injury have been reported in association with fosinopril therapy, but they have been too few to characterize the pattern of injury reliably. The onset of symptoms was within 2 to 12 weeks of starting therapy and the serum enzyme pattern was cholestatic. In one instance, cholestasis was prolonged and relapsing and associated with persistent elevations in serum alkaline phosphatase and GGT, suggestive of vanishing bile duct syndrome (Case 1). In published cases, immunoallergic manifestations (rash, fever, eosinophilia) were infrequent and patients did not develop autoantibodies. Other ACE inhibitors have been occasionally associated with a hepatocellular pattern of liver injury and cases with a long latency (one or more years) have been described as well. These features have not been clearly linked to fosinopril hepatotoxicity.

Likelihood score: D (possible rare cause of clinically apparent liver injury).

### Mechanism of Injury

The cause of the minor serum aminotransferase elevations with fosinopril therapy is not known. The cases of clinically apparent liver injury due to fosinopril were clearly idiosyncratic and likely due to a reaction to a metabolite. Fosinopril is hydrolyzed in the liver to its active metabolite fosinoprilat.

### Outcome and Management

Most instances of acute liver injury reported with fosinopril use have been self limited, but there have been rare reports of acute liver failure due to other ACE inhibitors as well as reports of cholestatic hepatitis leading to prolonged jaundice. Patients with severe fosinopril induced acute liver injury should avoid use of other ACE inhibitors, although cross sensitivity to liver injury among the members of this class of agents has not always been shown.

References to the safety and potential hepatotoxicity of fosinopril are given in the Overview section on the Angiotensin-Converting Enzyme (ACE) Inhibitors.

Drug Class: Antihypertensive Agents, Angiotensin-Converting Enzyme Inhibitors

## CASE REPORT

### Case 1. Acute hepatitis due to fosinopril.

[Modified from: Nunes AC, Amaro P, Maçias F, et al. Fosinopril-induced prolonged cholestatic jaundice and pruritus: first case report. Eur J Gastroenterol Hepatol 2001; 13: 279-82.] PubMed Citation (https://www.ncbi.nlm.nih.gov/pubmed/11293449)]

A 61 year old man with hypertension and a history of aortic aneurysm developed jaundice and pruritus 3 weeks after starting fosinopril (20 mg daily), metoprolol (50 mg twice daily), and diazepam (5 mg daily). Two weeks later he sought medical advice. He had no history of liver disease or risk factors for viral hepatitis. His serum enzymes had been normal on several occasions during the previous few months. He drank the equivalent of 3 to 4 alcoholic beverages daily (40 grams/day). He was taking no other medications. Physical examination showed jaundice but no fever, rash or peripheral manifestations of chronic liver disease. Laboratory testing showed marked elevation in serum bilirubin (19.1 mg/dL) and alkaline phosphatase (421 U/L), with only modest elevations in serum aminotransferase levels (ALT 70 U/L, AST 47 U/L) (Table). Tests for acute hepatitis A, B and C were negative and autoantibody tests were negative. He had no eosinophilia or elevations in immunoglobulin levels. Abdominal ultrasound and computerized tomography showed no evidence of gallstones or biliary obstruction. A liver biopsy showed severe intrahepatic cholestasis, but no bile duct damage and no changes suggestive of alcoholic liver disease. All medications were stopped on admission and he was treated with ursodiol, colestipol and hydroxyzine for the cholestasis and pruritus. He improved slowly and had multiple complications during a two month period of hospitalization (renal failure requiring dialysis, duodenal ulcer bleeding, and septicemia). He remained jaundiced for 4 months, had troublesome pruritus for 6 months, and still had marked elevations in serum alkaline phosphatase and occasional episodes of pruritus 18 months after his initial presentation.

#### Key Points

Medication: | Fosinopril (20 mg daily)
Pattern: | Cholestatic (R=0.4)
Severity: | 4+ (jaundice, hospitalization, other organ failure)
Latency: | 3 weeks
Recovery: | Partial over 6-18 months
Other medications: | Metoprolol, diazepam

#### Laboratory Values

Time After Starting* | Time After Stopping | GGT* (U/L) | Alk P* (U/L) | Bilirubin* (mg/dL) | Other
1.2 months | 0 | 73 | 421 | 19.1 | Admission
2 months | 1 month | 55 | 260 | 40.0 | Liver biopsy
3 months | 2 month | 40 | 230 | 13.0 | Discharge
5 months | 4 months | 75 | 580 | 1.0 | Pruritus requiring therapy
9 months | 8 months | 80 | 410 | 1.0
1year | 1 year | 90 | 300 | 1.0
1.5 years | 1.5 years | 95 | 320 | 1.0 | Minimal pruritus
Normal Values | | <50 | <117 | <1.2

* Values and dates in Table estimated from Figure 2.

#### Comment

The patient developed a severe acute cholestatic hepatitis within a few weeks of starting fosinopril which worsened for a month despite stopping therapy. A liver biopsy showed severe cholestasis, but without evidence of bile duct injury. The subsequent course, however, was typical for vanishing bile duct syndrome although the amount of bile duct loss was obviously not severe enough to result in frank biliary cirrhosis or hepatic failure. Slow and sometimes incomplete recovery is typical of severe cholestatic hepatitis due to medications.

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Fosinopril – Generic, Monopril®

DRUG CLASS

Angiotensin-Converting Enzyme Inhibitors

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Fosinopril)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Fosinopril | 98048-97-6 | C30-H46-N-O7-P | Fosinopril Chemical Structure

## OTHER REFERENCE LINKS

1. Recent References on Fosinopril: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(Fosinopril/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D%3A%222999/12/31%22%5BEDat%5D))
2. Trials on Fosinopril: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Fosinopril)